# Fexinidazole

## OVERVIEW

### Introduction

Fexinidazole is a nitroimidazole antimicrobial agent used to treat African trypanosomiasis, a severe and usually fatal parasitic infection caused by Trypanosoma brucei gambiense, also known as sleeping sickness. Fexinidazole is commonly associated with serum aminotransferase elevations when given in high doses for more than a few weeks, but elevations are uncommon and generally mild and transient when fexinidazole is given in the recommended doses for 10 days for African trypanosomiasis.

### Background

Fexinidazole (fex” i nid’ a zole) is a nitroimidazole antimicrobial agent developed as therapy for African trypanosomiasis, the severe parasitic infection also known as sleeping sickness. The disease is caused by infection with Trypanosoma brucei gambiense, a protozoa transmitted by the bite of the tsetse fly and found in Subsaharan Africa and occasionally among travelers returning from endemic areas, most commonly from the Central African Republic and the Democratic Republic of the Congo. African trypanosomiasis presents initially with intermittent fever, headaches, muscle and joint aches, weight loss and lymphadenopathy. During this early stage (Stage 1) of infection, trypanosomes are found in the bloodstream and lymph nodes only. With time, late stage symptoms of central nervous system involvement arise (Stage 2) with daytime sleepiness, personality changes, confusion and stupor followed by coma. In this stage, the trypanosomes are also detectable in cerebral spinal fluid and meninges. Fexinidazole was developed as therapy for African trypanosomiasis by the Drugs for Neglected Diseases Initiative in collaboration with Sanofi, a pharmaceutical company that had shelved the drug many years previously. In prospective controlled trials, a ten day course of oral fexinidazole was found to be non-inferior to the previous standard therapy of African trypanosomiasis, which requires 10 days of oral nifurtimox with 7 days of twice daily intravenous infusions of eflornithine (NECT), a difficult regimen in resource limited areas where trypanosomiasis is found. Fexinidazole was approved in the United States in 2021 and made available as tablets of 600 mg. The recommended dose in adults is 1800 mg once daily for 4 days followed by 1200 mg once daily for another 6 days. Lower doses are used in children [ages 6 years or older] below 35 but at least 20 kilograms in weight. Formal indications are for both first and second stage African trypanosomiasis due to infection with Trypanosoma brucei gambiense, but fexinidazole also appears to be effective for cases due to Trypanosoma brucei rhodesiense. Adverse events can include headache, nausea and vomiting, insomnia, fatigue, tremor, dizziness, poor appetite, back and abdominal pain, hyperkalemia and hypocalcemia – symptoms and abnormalities that are also frequent with the underlying disease. Rare but potentially severe adverse events include prolongation of the QTc interval, neuropsychiatric reactions, agitation, hallucinations, neutropenia, and alcohol reactions for which reason alcohol should be prohibited during therapy and concomitant medications scrutinized for possible drug-drug interactions or additive adverse effects.

### Hepatotoxicity

Fexinidazole therapy was not associated with elevations in aminotransferase or bilirubin levels or with clinically apparent liver injury during the ten day regimens used to treat African trypanosomiasis. However, evaluation of longer courses of therapy and use of higher doses in Chagas disease caused by Trypanosoma cruzi demonstrated several instances of ALT or AST elevations above 3 times the upper limit of normal (ULN), which persisted for as long as 3 months after stopping fexinidazole. The enzyme elevations were usually hepatocellular and arose after 2 weeks of therapy. The liver injury was asymptomatic and not associated with jaundice or with rash, fever or other signs of hypersensitivity. Nevertheless, the hepatic injury as well as delayed neutropenia led to discontinuation of the clinical trials of fexinidazole in high doses in Chagas disease. Since approval of fexinidazole for African trypanosomiasis, there have been no individual reports of liver injury associated with its use.

Likelihood score: E* (unlikely but suspected cause of clinically apparent liver injury when given in the recommended regimens for African trypanosomiasis).

### Mechanism of Injury

The mechanism by which fexinidazole causes liver injury is unknown. Fexinidazole is a prodrug that is activated to an reactive metabolite by parasites but not in human cells. It acts by binding tubulin in parasitic worms which it does with greater avidity than the tubulin in mammalian cells, but some of the toxicity of the may be related to this tubulin-binding activity.

### Outcome and Management

Fexinidazole is usually well tolerated, and the liver injury reported with its use arose in regimens for Chagas disease which employed higher doses for a longer period. Similar episodes of hepatocellular injury have been reported with other nitroimidazoles and benzimidazoles. It is unknown whether there is cross sensitivity with these other antiparasitic agents.

Drug Class: Antiinfective Agents, Trypanosomiasis Agents

Other Drugs in the Subclass, Nitroimidazoles: Benznidazole, Metronidazole, Secnidazole, Tinidazole

Other Trypanosomiasis Agents: Benznidazole, Nifurtimox

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fexinidazole – Fexinidazole®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fexinidazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fexinidazole | 59729-37-2 | C12-H13-N3-O3-S

## ANNOTATED BIBLIOGRAPHY

References updated: 18 July 2023

Abbreviations used: NECT, nifurtimox and eflornithine combination therapy.

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of drugs for parasite infections written in 1999, before the availability of drugs for trypanosomiasis).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections: amebiasis, giardiasis, trichomoniasis, trypanosomiasis, Leishmaniasis, and other protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-99. (Textbook of pharmacology and therapeutics).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin American published between 1996 and 2012, none were attributed for agents used to treat trypanosomiasis including Chagas disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to medications for parasitic diseases). 25754159
Maxmen A. Sleeping sickness can now be cured with pills. Nature. 2017;550:441. (News report describing the successful results of all oral therapy with fexinidazole in African trypanosomiasis [91% response rates], the result of a collaboration between the non-profit research organization “Drugs for Neglected Diseases” initiative and the Sanofi pharmaceutical company). 29072286
Mesu VKBK, Kalonji WM, Bardonneau C, Mordt OV, Blesson S, Simon F, Delhomme S, et al. Oral fexinidazole for late-stage African Trypanosoma brucei gambiense trypanosomiasis: a pivotal multicentre, randomised, non-inferiority trial. Lancet. 2018;391:144-154. (Among 394 patients [ages 15 years or above] with late stage African trypanosomiasis treated with fexinidazole or NECT therapy for 20 days, success rates at 18 months after enrollment were 91% vs 98% [a non-inferior result], and adverse events rates were similar [94% vs 92%] including severe adverse events [12% vs 10%]; and while ALT elevations and hepatotoxicity were not specifically mentioned, “There were no clinically significant changes in any…laboratory values over the duration of treatment”). 29113731
Pelfrene E, Harvey Allchurch M, Ntamabyaliro N, Nambasa V, Ventura FV, Nagercoil N, Cavaleri M. The European Medicines Agency's scientific opinion on oral fexinidazole for human African trypanosomiasis. PLoS Negl Trop Dis. 2019;13:e0007381. (The European Medicines Agency’s scientific report on the efficacy and safety of oral fexinidazole as therapy for African trypanosomiasis endorsing its use in Europe as well as regions outside the European Union where the disease is endemic and a major cause of morbidity and mortality). 31246956
Deeks ED. Fexinidazole: first global approval. Drugs. 2019;79:215-220. (Review of the history of development, mechanism of action, pharmacokinetics, clinical efficacy, and safety of fexinidazole shortly after its approval by the European Medicines Agency makes no mention of ALT elevations or hepatotoxicity). 30635838
Kande Betu Ku Mesu V, Mutombo Kalonji W, Bardonneau C, Valverde Mordt O, Ngolo Tete D, Blesson S, Simon F, et al. Oral fexinidazole for stage 1 or early stage 2 African Trypanosoma brucei gambiense trypanosomiasis: a prospective, multicentre, open-label, cohort study. Lancet Glob Health. 2021;9:e999-e1008. (Among 232 patients with early stage African trypanosomiasis treated with open-label fexinidazole, the response rate at 12 months was 98% and adverse events were frequent [93%] but did not result in deaths or treatment discontinuation and there were no “acute or delayed liver abnormalities”). 34143998
Kande Betu Kumesu V, Mutombo Kalonji W, Bardonneau C, Valverde Mordt O, Ngolo Tete D, Blesson S, Simon F, et al. Safety and efficacy of oral fexinidazole in children with gambiense human African trypanosomiasis: a multicentre, single-arm, open-label, phase 2-3 trial. Lancet Glob Health. 2022;10:e1665-e1674. (Among 125 children with stage 1 or early stage 2 African trypanosomiasis treated with open-label fexinidazole [either 1800 mg for 4 days followed by 1200 mg for 6 days, or 1200 mg followed by 600 mg if body weight <35 kilograms], the 12 month success rate was 98% and adverse events were frequent but mostly mild-to-moderate and “Assessment of laboratory values…did not raise any safety concerns”). 36179736
Torrico F, Gascón J, Ortiz L, Pinto J, Rojas G, Palacios A, Barreira F, et al. A phase 2, randomized, multicenter, placebo-controlled, proof-of-concept trial of oral fexinidazole in adults with chronic indeterminate Chagas Disease. Clin Infect Dis. 2023;76:e1186-e1194. (Among 47 adults with chronic indeterminate Chagas disease treated with 1 of 6 regimens of fexinidazole given orally for 2, 4 or 8 weeks or placebo [n=7], rapid sustained clearance of parasitemia was achieved in all subjects but adverse events included delayed onset neutropenia [20%] and serum aminotransferase elevations [16: 40% above 3 times ULN], which often arose after therapy was stopped and persisted beyond 3 months in 23% but were asymptomatic and ultimately resolved in all). 35925555

## OTHER REFERENCE LINKS

1 Recent References on Fexinidazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fexinidazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fexinidazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fexinidazole)